# Bedaquiline

## OVERVIEW

### Introduction

Bedaquiline is a diarylquinoline antimycobacterial drug used in combination with other antituberculosis medications in the treatment of multidrug resistant tuberculosis. The addition of bedaquiline to antituberculosis drug regimens has been linked to an increased rate of transient serum liver test abnormalities during treatment and to several instances of clinically apparent liver injury.

### Background

Bedaquiline (bed ak' wi leen) is relatively newly approved antimycobacterial agent that has been shown to have activity against multidrug resistant mycobacterium tuberculosis both in vitro and in vivo. The mechanism of action of bedaquiline is unique: it is a diarylquinoline and is believed to act via inhibition of mycobacterial ATP synthetase; mammalian ATP synthetases not being susceptible. Bedaquiline was approved for use in pulmonary, multidrug resistant tuberculosis in combination with other antituberculosis agents in the United States in 2012 and was the first drug approved for therapy of tuberculosis is over 40 years. It is not approved for use in latent or drug sensitive tuberculosis or in atypical mycobacterial infections. In addition, bedaquiline has not been proven to be effective for extra-pulmonary tuberculosis. Bedaquiline is available in tablets of 100 mg under the brand name Sirturo. The typical dose is 400 mg once daily for 2 weeks followed by 200 mg three times weekly. Common side effects include nausea, arthralgias, headache, chest pain and rash. Bedaquiline also increases the QTc interval, but has not been linked to sudden death. On the other hand, prelicensure studies showed that patients on bedaquiline therapy had an excess mortality rate in comparison to those on placebo, a finding that has not been adequately explained and for which reason its use is restricted. Regularly updated recommendations on the use of bedaquiline and other drugs for tuberculosis, including indications, contraindications, warnings, dosages and monitoring recommendations are available at the Centers for Disease Control and Prevention website: http://www.cdc.gov/tb/publications/guidelines/Treatment.htm.

### Hepatotoxicity

Liver test abnormalities occur in 8% to 12% of patients treated with multiple drug regimens that include bedaquiline. These abnormalities are usually asymptomatic, mild-to-moderate in severity and self-limited in duration. In many instances, it is difficult to determine which of the antituberculosis medications accounts for the abnormalities, but monitoring of liver tests at monthly intervals is recommended during bedaquiline therapy. Clinically apparent liver injury has been reported with bedaquiline therapy, but the clinical features, course and outcome of these cases has not been described. At least three deaths from end stage liver disease have been described in patients taking bedaquiline, but the attribution of the hepatic failure to bedaquiline has been questioned. The management of multidrug resistant tuberculosis is challenging and should be under the direction of physicians with expertise in tuberculosis therapy.

Likelihood score: E* (unproven but suspected cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which bedaquiline causes serum aminotransferase elevations is not known, but is likely due to production of a toxic intermediate by its metabolism. Bedaquiline is metabolized by the liver via the P450 system (predominantly CPY 3A4) and it is susceptible to drug-drug interactions with agents that induce or inhibit CYP3A4.

### Outcome and Management

Patients on bedaquiline should be monitored with monthly liver tests, including serum bilirubin, ALT, AST and alkaline phosphatase. Bedaquiline should be discontinued for persistent increases in liver test abnormalities, ALT elevations above 8 times the upper limit of normal, elevations of bilirubin more than twice normal or any symptom or sign of liver injury. There does not appear to be cross sensitivity to liver injury or adverse events between bedaquiline and other antituberculosis medications.

Drug Class: Antituberculosis Agents

Other Drugs in the Class: Capreomycin, Cycloserine, Ethambutol, Ethionamide, Isoniazid, Pyrazinamide, Rifabutin, Rifampin, Rifapentine, Streptomycin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Bedaquiline – Sirturo®

DRUG CLASS

Antituberculosis Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Bedaquiline)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Bedaquiline | 843663-66-1 | C32-H31-Br-N2-O2 | Bedaquiline Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 22 September 2017

Zimmerman HJ. Antituberculosis agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 611-21. (Extensive review of hepatotoxicity of antituberculosis medications published in 1999 before the availability of bedaquiline).
Verma S, Kaplowitz N. Hepatotoxicity of antituberculosis drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 483-504. (Review of hepatotoxicity of antituberculosis drugs).
Gumba T. Chemotherapy of tuberculosis, mycobacterium avium complex disease and leprosy. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman.s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1549-70. (Textbook of pharmacology and therapeutics).
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were linked to bedaquiline). 20949552
Diacon AH, Donald PR, Pym A, Grobusch M, Patientia RF, Mahanyele R, Bantubani N, et al. Randomized pilot trial of eight weeks of bedaquiline (TMC207) treatment for multidrug-resistant tuberculosis: long-term outcome, tolerability, and effect on emergence of drug resistance. Antimicrob Agents Chemother 2012; 56: 3271-6. (Among 47 patients with multidrug resistant tuberculosis treated with bedaquiline or placebo with background regimens for up to 6 months, major side effects not mentioned). 22391540
Centers for Disease Control and Prevention. Provisional CDC guidelines for the use and safety monitoring of bedaquiline fumarate (Sirturo) for the treatment of multidrug-resistant tuberculosis. MMWR Recomm Rep 2013 Oct 25; 62 (RR-09): 1-12. (Recommendations on use of bedaquiline mentions that patients should be monitored monthly and bedaquiline should be discontinued for persistent aminotransferase elevations, combined elevations of ALT or AST and bilirubin, ALT or AST elevations above 8 times the ULN, or any liver test abnormalities accompanied by symptoms of liver injury). 24157696
Chan B, Khadem TM, Brown J. A review of tuberculosis: Focus on bedaquiline. Am J Health Syst Pharm 2013; 70: 1984-94. (Review of the pharmacology, mechanism of action, efficacy and safety of bedaquiline mentions that liver test abnormalities were more frequent with bedaquiline than placebo [9% vs 2%], but abnormalities were transient in all except 2 patients). 24173008
Fox GJ, Menzies D. A Review of the Evidence for Using Bedaquiline (TMC207) to Treat Multi-Drug Resistant Tuberculosis. Infect Dis Ther 2013; 2: 123-44. (Review of the published and unpublished results of trials of bedaquiline in multidrug resistant tuberculosis mentions that two patients treated in prelicensure studies developed liver injury after being placed on bedaquiline, and died 3 months and 1 year after stopping the drug). 25134476
Chahine EB, Karaoui LR, Mansour H. Bedaquiline: a novel diarylquinoline for multidrug-resistant tuberculosis. Ann Pharmacother 2014; 48: 107-15. (Review of trials of bedaquiline vs placebo in multidrug resistant tuberculosis mentions that there was a statistically significant higher rate of death among bedaquiline treated patients, "the exact cause of this difference in mortality is unknown"). 24259600
Kakkar AK, Dahiya N. Bedaquiline for the treatment of resistant tuberculosis: promises and pitfalls. Tuberculosis (Edinb) 2014; 94: 357-62. (Review of the role of bedaquiline in management of multidrug resistant tuberculosis mentions that elevated aminotransferase levels were found in 11% of bedaquiline vs 1% of placebo recipients). 24841672
Guglielmetti L, Le Dû D, Jachym M, Henry B, Martin D, Caumes E, Veziris N, et al.; MDR-TB Management Group of the French National Reference Center for Mycobacteria and the Physicians of the French MDR-TB Cohort. Compassionate use of bedaquiline for the treatment of multidrug-resistant and extensively drug-resistant tuberculosis: interim analysis of a French cohort. Clin Infect Dis 2015; 60: 188-94. (Retrospective analysis of 35 patients with multidrug resistant tuberculosis treated with bedaquiline mentions mild liver enzyme elevations in 5 [14%], but these were asymptomatic and transient in all, not requiring dose modification). 25320286
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: the DILIN prospective study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 408 were attributed to antimicrobial agents including 52 to antituberculosis agents, but no cases were attributed to bedaquiline). 25754159
Pym AS, Diacon AH, Tang SJ, Conradie F, Danilovits M, Chuchottaworn C, Vasilyeva I, et al; TMC207-C209 Study Group. Bedaquiline in the treatment of multidrug- and extensively drug-resistant tuberculosis. Eur Respir J 2016; 47: 564-74. (Among 233 adults with multidrug and extensively resistant tuberculosis treated with bedaquiline in combination with conventional agents for up to 120 weeks, sputum cultures became negative in ~70% of patients; while 5% had ALT elevations and one developed hepatitis with jaundice, there were no deaths or severe hepatic adverse events that were considered related to therapy). 26647431
Guglielmetti L, Jaspard M, Le Dû D, Lachâtre M, Marigot-Outtandy D, Bernard C, Veziris N, et al; French MDR-TB Management Group. Long-term outcome and safety of prolonged bedaquiline treatment for multidrug-resistant tuberculosis. Eur Respir J 2017; 49. pii: 1601799. (Among 45 adults with multidrug-resistant tuberculosis treated with bedaquiline in combination with conventional agents, liver enzyme elevations occurred in 38% but no patient stopped therapy for ALT elevations, had a serious liver related adverse event, or died from liver related causes). 28182570

## OTHER REFERENCE LINKS

1. Recent References on Bedaquiline: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Bedaquiline+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Bedaquiline: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Bedaquiline)